# Cilostazol

## OVERVIEW

### Introduction

Cilostazol is a quinolinone derivative that inhibits specific cellular phosphadiesterases, which cause arterial vasodilation and inhibition of platelet function and makes it a valuable as a therapy of intermittent claudication and as a means of secondary prevention of stroke. Cilostazol has not been associated with serum enzyme elevations during therapy or with published instances of clinically apparent liver injury.

### Background

Cilostazol (sye loe' sta zol) acts by semi-selective inhibition of phosphodiesterase III, which causes an increase in intracellular cyclic AMP resulting in arterial vasodilation and inhibition of platelet aggregation. Cilostazol is used largely to treat symptoms of intermittent claudication due to peripheral vascular disease where it has been shown to increase pain-free walking distance and improve exercise tolerance. Cilostazol has also been evaluated as an antiplatelet agent and is used off-label as a means of prevention of recurrent stroke. Cilostazol was approved in the United States in 1999 and is widely used with more than one million prescriptions filled yearly. Current indications are limited to treatment of symptoms of intermittent claudication. Cilostazol is available in tablets of 50 and100 mg in several generic forms and under the brand name Pletal. The recommended maintenance dose is 100 mg twice daily. Side effects can include headache, dizziness, tachycardia, palpitations, diarrhea and peripheral edema. Rare, but serious adverse events include thrombocytopenia and agranulocytosis.

### Hepatotoxicity

In publications of the multiple, large prospective trials of cilostazol therapy, rates of serum ALT elevations during therapy were not provided. Furthermore, there were no reported instances of clinically apparent acute liver injury. Since its approval and wide scale use, there have been no published reports of hepatotoxicity attributed to cilostazol. Nevertheless, the current product label mentions that instances of serum enzyme elevations and hepatitis have been reported to the sponsor. The time of onset, clinical pattern and course of liver test abnormalities during cilostazol therapy have not been reported.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which cilostazol might cause liver injury is not known, but it is metabolized in the liver, largely by cytochrome P450 (CYP) 3A4 and to a lesser extent by CYP 2C19. Thus, cilostazol is potentially susceptible to drug-drug interactions from inhibitors of CYP 3A4 (ketoconazole, erythromycin) and CYP 2C19 (omeprazole), and liver injury may be caused by a toxic or antigen product of its metabolism.

### Outcome and Management

The course and outcome of liver injury from cilostazol has not been reported.

Drug Class: Cardiovascular Drugs, Intermittent Claudication Agents

Other Drugs in the Subclass, Intermittent Claudication Agents: Pentoxifylline

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Cilostazol – Generic, Pletal®

DRUG CLASS

Intermittent Claudication Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Cilostazol)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Cilostazol | 73963-72-1 | C20-H27-N5-O2 | Image of Cilostazol Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 1 December 2017

Zimmerman HJ. Pentoxifylline. Drugs used in cardiovascular disease. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 654. (Expert review of hepatotoxicity published in 1999, does not discuss cilostazol).
Michel T, Hoffman BB. Treatment of myocardial ischemia and hypertension. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 746-88. (Textbook of pharmacology and therapeutics).
Cameron HA, Waller PC, Ramsay LE. Drug treatment of intermittent claudication: a critical analysis of the methods and findings of published clinical trials, 1965-1985. Br J Clin Pharmacol 1988; 26: 569-76 (Analysis of 75 trials of 33 drugs used to treat intermittent claudication in the English literature [1965-1985: before availability of cilostazol] found design problems in 76% of trials and concluded that available information does not support the efficacy of any agent in exercise performance in intermittent claudication). 3061424
Dawson DL, Cutler BS, Hiatt WR, Hobson RW 2nd, Martin JD, Bortey EB, Forbes WP, et al. A comparison of cilostazol and pentoxifylline for treating intermittent claudication. Am J Med 2000; 109: 523-30. (Among 698 patients with intermittent claudication treated with cilostazol [100 mg twice daily], pentoxifylline [400 mg thrice daily] or placebo, maximal walking distance improved more with cilostazol [54%] than pentoxifylline [30%], which was similar in effect to placebo [34%]; adverse events were similar in all 3 groups; no mention of ALT levels or hepatotoxicity). 11063952
Pratt CM. Analysis of the cilostazol safety database. Am J Cardiol 2001; 8: 28D-33D. (Summary of adverse events from 8 controlled trials of cilostazol [50 to 100 mg twice daily for 12-24 weeks] in 1374 patients with intermittent claudication states that rates of serious adverse events were no different than with placebo; in postmarketing surveillance of 70,430 patients over a 3 year period in the US, 461 adverse events were reported, 34 considered serious, none of which were judged to be drug related; no mention of ALT elevations or hepatotoxicity). 11434897
Strandness DE Jr, Dalman RL, Panian S, Rendell MS, Comp PC, Zhang P, Forbes WP. Effect of cilostazol in patients with intermittent claudication: a randomized, double-blind, placebo-controlled study. Vasc Endovascular Surg 2002; 36: 83-91. (Among 394 patients with intermittent claudication treated with cilostazol [50 or 100 mg twice daily] or placebo for 24 weeks, the most common adverse events were headache [26% and 41% vs 12%], diarrhea [11% and 17% vs 6%] and there were no "clinically relevant changes in laboratory assessments"; no specific mention of ALT elevations or hepatotoxicity). 11951094
Chapman TM, Goa KL. Cilostazol: a review of its use in intermittent claudication. Am J Cardiovasc Drugs 2003; 3: 117-38. (Review of the mechanism of action, efficacy and safety of cilostazol based upon 8 controlled trials in 2274 patients mentions that side effects are common, but generally well tolerated and cilostazol has significant drug-drug interactions with CYP 3A4 and 2C19 inducers; no mention of ALT elevations or hepatotoxicity). 14727939
Drugs for intermittent claudication. Med Lett Drugs Ther 2004; 46 (1176): 13-5. (Concise review of the medical management of intermittent claudication mentions that pentoxifylline is approved for symptomatic therapy of this condition, but that its efficacy is controversial; no mention of ALT elevations or hepatotoxicity). 14973403
Morris DS, Porterfield JR, Sawyer MD. Hemorrhagic cholecystitis in an elderly patient taking aspirin and cilostazol. Case Rep Gastroenterol 2008; 2: 203-7. (91 year old woman with intermittent claudication developed hemorrhagic cholecystitis after having taken both aspirin and cilostazol for 4 years). 21490889
Hiatt WR, Money SR, Brass EP. Long-term safety of cilostazol in patients with peripheral artery disease: the CASTLE study (Cilostazol: A Study in Long-term Effects). J Vasc Surg 2008; 47: 330-6. (Among 1435 patients with intermittent claudication treated with cilostazol [100 mg twice daily] or placebo for up to 3 years, death rates [1.9 vs 2.2 patients per year] and rates of serious bleeding were not different [2.5 vs 3.1]; no mention of ALT elevations or hepatotoxicity). 18155871
Shinohara Y, Katayama Y, Uchiyama S, Yamaguchi T, Handa S, Matsuoka K, Ohashi Y, et al.; CSPS 2 group. Cilostazol for prevention of secondary stroke (CSPS 2): an aspirin-controlled, double-blind, randomized non-inferiority trial. Lancet Neurol 2010: 959-68. (Among 2757 patients with stroke treated with cilostazol [100 mg twice daily] or aspirin for up to 5 years [m=29 months], there were no differences in rates of serious adverse events and no mention of ALT elevations or hepatotoxicity). 20833591
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but none were attributed to cilostazol). 20949552
Stevens JW, Simpson E, Harnan S, Squires H, Meng Y, Thomas S, Michaels J, et al. Systematic review of the efficacy of cilostazol, naftidrofuryl oxalate and pentoxifylline for the treatment of intermittent claudication. Br J Surg 2012; 99: 1630-8. (Systematic review of the literature on drugs for intermittent claudication concluded that pentoxifylline was less effective than cilostazol, that adverse events were "generally minor" and that serious adverse events were not increased; no mention of ALT elevations or hepatotoxicity). 23034699
Lee WH, Chu CY, Hsu PC, Su HM, Lin TH, Voon WC, Lai WT, Sheu SH. Cilostazol for primary prevention of stroke in peripheral artery disease: a population-based longitudinal study in Taiwan. Thromb Res 2013; 132: 190-5. (Retrospective cohort study of patients with intermittent claudication in Taiwan treated with cilostazol, aspirin or clopidogrel, found rates for stroke were lower in cilostazol treated subjects; no mention of ALT elevations or hepatotoxicity). 23433530
Perez P, Esteban C, Sauquillo JC, Yeste M, Manzano L, Mujal A, Jiméz Caballero PE, et al.; FRENA Investigators. Cilostazol and outcome in outpatients with peripheral artery disease. Thromb Res 2014; 134: 331-5. (Among 1317 patients with intermittent claudication followed in a prospective database, patients on cilostazol [n=191] had similar rates of ischemic stroke, major bleeding and death to those not on cilostazol; no mention of ALT elevations or hepatotoxicity). 24951338
Rogers KC, Oliphant CS, Finks SW. Clinical efficacy and safety of cilostazol: a critical review of the literature. Drugs 2015; 75: 377-95. (Review of the mechanism of action, pharmacology, efficacy and safety of cilostazol; no mention of ALT elevations or hepatotoxicity). 25758742
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, none were attributed to cilostazol). 25754159

## OTHER REFERENCE LINKS

1. Recent References on Cilostazol: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Cilostazol+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Cilostazol: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Cilostazol)